# Cyproheptadine

## OVERVIEW

### Introduction

Cyproheptadine is a first generation antihistamine used in the treatment of allergic rhinitis and urticaria and as an appetite stimulant. Cyproheptadine has been linked to rare instances of clinically apparent liver injury.

### Background

Cyproheptadine (sye" proe hep' da deen) is a first generation antihistamine which also has anticholinergic and antiserotonergic activities that is used to treat allergic conditions including seasonal rhinitis, conjunctivitis, dermatitits and urticaria. Cyproheptadine belongs to the piperidine class of antihistamines. Its antiserotonergic properties have led to its use to treat side effects of the serotonin reuptake inhibitors and the serotonin syndrome. Cyproheptadine has also been used off-label as an appetite stimulant and to treat cyclic vomiting. Cyproheptadine is available by prescription only. Formulations include tablets, oral solutions and syrups in multiple generic forms and under the trade name Periactin. The usual adult oral dose is 4 mg three to four times daily. Common side effects include excessive sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and precipitate acute narrow angle glaucoma.

### Hepatotoxicity

Unlike most first generation antihistamines, cyproheptadine has been associated with several instances of clinically apparent liver injury. The few cases that have been described had a time to onset of 1 to 6 weeks and a cholestatic or mixed pattern of liver enzyme elevations. Immunoallergic and autoimmune features were not present and most patients recovered rapidly without residual. Acute liver failure due to cyproheptadine has not been described.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury due to cyproheptadine is not known, but is clearly idiosyncratic and perhaps due to its hepatic metabolism to a toxic intermediate.

### Outcome and Management

Most instances of acute liver injury due to cyproheptadine have been mild-to-moderate in severity and self-limited in course and outcome. In one case report, there was recurrence of injury when cyproheptadine was restarted. There is no information on cross sensitivity to hepatic injury among the various antihistamines, but use of an antihistamine of another class after clinically apparent liver injury due to cyproheptadine is likely to be safe.

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cyproheptadine – Generic, Periactin®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cyproheptadine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cyproheptadine | 129-03-3 | C21-H21-N | Cyproheptadine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Cyproheptadine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cyproheptadine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cyproheptadine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cyproheptadine)